# Areca Nut

## OVERVIEW

### Introduction

Areca nut, commonly known as betel nut, is the fruit of the Areca palm (Areca catechu), which is found in tropical areas of the Pacific, south Asia and eastern Africa. The major use of areca nut is as a recreational stimulant typically chewed wrapped in betel leaves (Piper betle), powdered with calcium hydroxide (slaked lime), and flavored with mint, clove or tobacco. Areca nut has also been used as an extract in traditional medicine as a cathartic or as treatment of intestinal parasites. Areca nut has not been linked to cases of clinically apparent acute liver injury, but epidemiologic studies from Asia have found a strong link between habitual betel nut chewing and oral cancer, and it may also increase the risk of cirrhosis and hepatocellular carcinoma.

### Background

Areca nut is not a nut but rather the seed containing fruit of the areca palm (Areca catechu), which is found in tropical areas of the Pacific, South Asia and Western Africa, where it is frequently cultivated. Chewing areca nut for its recreational stimulant effect is the most common use of the herb which is also called betel nut chewing for the betel leaves (Piper betle) in which the areca nut is wrapped. Chewing areca nut releases a central nervous system stimulant that causes a heightened awareness, increased stamina, euphoria and feeling of well-being. Betel nut chewing is the fourth most common form of substance abuse (after caffeine, alcohol, and nicotine) and is practiced by 10% of the world’s population. The active components of areca nut are thought to be the arecal alkaloids, including arecoline, arecaidine, guvacine and guvacolin which have cholinergic (predominantly muscarinic) and other psychoactive properties. Other ingredients include tannins, such as arecatannin and gallic acid, oil gum, and lignin. Habitual betel nut chewing is associated with serious long term health risks including cancer, heart disease and cirrhosis.

In India and China, areca nut extracts have also been used in traditional medicine as treatment of parasitic diseases and to improve digestion, diarrhea, abdominal distension, dyspepsia and jaundice. The only widely accepted medicinal use of Areca catechu at present is in veterinary medicine where it is used as a cathartic and treatment for tapeworm in horses, cattle and dogs. Areca nut is considered unsafe for human consumption by the U.S. Food and Drug Administration (FDA), and it is not approved for any medical condition. Nevertheless, arena nut is available over-the-counter in the United States and in Europe, typically in Asian markets in forms that can be used in chewing. Areca catechu nut chewing is most common in India, Pakistan, southeast Asia, Micronesia, and western Africa. In these areas, areca catechu nut use disorders are common and are the focus of government and public health efforts to decrease its use. Adverse events associated with use of Areca catechu extracts have not been well defined, but chewing betel nut is associated with palpitations, arrhythmias, hypotension, chest pain, dyspnea, tachypnea, acute myocardial infarction, chronic kidney disease, and nephrolithiasis. Importantly, areca nut has carcinogenic potential in vitro and in vivo, and long term, habitual betel nut chewing has been linked to oral and esophageal cancer. In addition, cross sectional population based and cohort studies have suggested that betel nut chewing is also a risk factor for cirrhosis and hepatocellular carcinoma.

### Hepatotoxicity

There have been few studies on the clinical effects and adverse effects of betel nut chewing or of extracts of the areca nut. However, there have been no reports of acute liver injury and marked serum aminotransferase elevations attributed to betel nut chewing or of use of areca nut extracts. On the other hand, several cross sectional epidemiologic studies have linked regular betel nut chewing with a higher prevalence of hepatic cirrhosis and hepatocellular carcinoma. The excess risk of cirrhosis and liver cancer from areca nut use is independent and apparently synergistic with hepatitis B and C virus infection and nonalcoholic fatty liver disease.

Likelihood score for Areca catechu extract use: E (unlikely cause of clinically apparent acute liver injury).

Likelihood score for Areca catechu nut chewing: C (probable cause of increased risk of cirrhosis and hepatocellular carcinoma with habitual use).

### Mechanism of Injury

Areca nut has multiple components that might promote carcinogenesis, but the major candidate is the psychoactive areca alkaloids, including arecoline, arecaidine, guavacoline, and guavacine.

### Outcome and Management

Acute hepatotoxicity from areca nut has not been described. Habitual use of areca nut chewing should be discouraged, particularly in persons with underlying chronic liver disease, chronic alcohol abuse or fatty liver.

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Areca catechu – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Areca catechu | 89957-52-8 (https://pubchem.ncbi.nlm.nih.gov/substance/135273342) | Herbal | Not Applicable
Arecoline | 63-75-2 | C8-H13-N-O2

While areca catechu nut has multiple components, its major alkaloid is arecoline which is believed to be the active component responsible for its central nervous system stimulation.

## ANNOTATED BIBLIOGRAPHY

References updated: 22 March 2023

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not betel nut or Areca catechu).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; no mention of betel nut chewing or Areca catechu).
Areca catechu. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 19-26. (Compilation of short monographs on herbal medications and dietary supplements).
Boucher BJ, Mannan N. (2002). Metabolic effects of the consumption of Areca catechu. Addict Biol. (Areca or betel nut chewing is an addictive behavior practiced by at least 10% of the world’s population, the active ingredients of Areca catechu being the arecal alkaloids, arecoline, arecaidine, guvacine and guvacoline which have cholinergic and psychoactive properties).
Tsai JF, Jeng JE, Chuang LY, Ho MS, Ko YC, Lin ZY, Hsieh MY, et al. (2004). Habitual betel quid chewing and risk for hepatocellular carcinoma complicating cirrhosis. Medicine (Baltimore). (In a cross sectional, case control study of 630 Taiwanese adults, a history of habitual betel nut chewing was more frequent among patients with hepatocellular carcinoma [25%] and patients with cirrhosis without cancer [16%], than in healthy controls [5%]).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals in a Swedish Registry does not list Areca catechu among products associated with 5 or more reports).
Wu GH, Boucher BJ, Chiu YH, Liao CS, Chen TH. (2009). Impact of chewing betel-nut (Areca catechu) on liver cirrhosis and hepatocellular carcinoma: a population-based study from an area with a high prevalence of hepatitis B and C infections. Public Health Nutr. (In a population based study from Taiwan, betel nut chewing was found to be a risk for both cirrhosis and hepatocellular cancer [a 4-5 fold increase in prevalence] which was independent from and synergistic with HCV and HBV infection).
Peng W, Liu YJ, Wu N, Sun T, He XY, Gao YX, Wu CJ. (2015). Areca catechu L. (Arecaceae): a review of its traditional uses, botany, phytochemistry, pharmacology and toxicology. J Ethnopharmacol. (Extracts of Areca catechu have been used in Chinese and Indian traditional medicine for treatment of parasitic disease and to improve digestion, diarrhea, abdominal distension, dyspepsia and jaundice, while also being used as a stimulant (betel nut chewing), the fourth most common agent of abuse worldwide).
Liu YJ, Peng W, Hu MB, Xu M, Wu CJ. (2016). The pharmacology, toxicology and potential applications of arecoline: a review. Pharm Biol. (Review of the pharmacological activities of arecoline including effects on central nervous system, cardiac, digestive and endocrine system).
Chou YT, Li CH, Sun ZJ, Shen WC, Yang YC, Lu FH, Chang CJ, Wu JS. (2021). A positive relationship between betel nut chewing and significant liver fibrosis in NAFLD subjects, but not in non-NAFLD ones. Nutrients. (Among 5967 adults undergoing a general medical evaluation and abdominal ultrasound, a history of ongoing or previous areca nut chewing was more frequent among those with fatty liver than those without [7.4% vs 4.2%] and non-invasive measures of fibrosis were higher in those with fatty liver but not among those with a history of areca nut chewing who did not have fatty liver).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut, but not Areca catechu).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements but does not mention Areca catechu).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the General population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, 15 of which [16%] were attributed to HDS products, but none were listed as containing Areca catechu).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury does not mention Areca catechu).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products, but none were listed as containing Areca catechu).
Brown AC. (2017). Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol. (Description of an online compendium of cases of liver toxicity attributed to HDS products does not list Areca catechu or betel nut chewing in the compendium of implicated agents).
Osborne PG, Ko YC, Wu MT, Lee CH. (2017). Intoxication and substance use disorder to Areca catechu nut containing betel quid: a review of epidemiological evidence, pharmacological basis and social factors influencing quitting strategies. Drug Alcohol Depend. (Description and review of Areca catechu nut use disorder which affects an estimated 200 to 400 persons worldwide and is relatively understudied, even though habitual areca nut chewing is a major cause of oral and esophageal carcinoma).
Horenstein NA, Quadri M, Stokes C, Shoaib M, Papke RL. (2019). Cracking the betel nut: cholinergic activity of areca alkaloids and related compounds. Nicotine Tob Res. (Analysis of the cholinergic activity of the areca alkaloids indicates that while arecoline and guvacoline are both activators of muscarinic acetylcholine receptors, only arecoline has nicotinic acetylcholine receptor activity).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], while no cases were attributed to betel nut chewing or Areca catechu).
Tungare S, Myers AL. (2021). Retail availability and characteristics of addictive Areca nut products in a US metropolis. J Psychoactive Drugs. (Areca nut products were found to be available in all five South-Asian markets visited in Houston, Texas, often not labelled as to contents, concentrations, uses, or potential adverse effects and usually in forms that were meant to be used for betel nut chewing).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62], and greater celandine [48]; areca catechu nut was not listed among the 79 implicated products).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while none were attributed to Areca catechu).

## OTHER REFERENCE LINKS

1 Recent References on Areca catechu: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Areca+catechu+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Areca catechu: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Areca%20catechu)